# Vortioxetine

## OVERVIEW

### Introduction

Vortioxetine is a serotonergic antidepressant used for major depression disorders. Vortioxetine has been associated with a low rate of minor serum aminotransferase elevations during treatment, but has not been linked to instances of clinically apparent acute liver injury.

### Background

Vortioxetine (vor" tye ox' e teen) is a unique serotonergic antidepressant that is believed to have a bimodal activity, inhibiting serotonin reuptake, but also acting as a mixed agonist and antagonist directly on serotonin (5-HT) receptors. Vortioxetine has been shown to be effective in alleviating symptoms of depression in patients with major depression disorder. Vortioxetine was approved for use in the United States in 2013 for use in treatment of major depression disorders. There is limited clinical experience with its use. Vortioxetine is available in tablets of 5, 10, 15 and 20 mg under the commercial name Trintellix. The recommended dose is 10 mg once daily initially, with subsequent increase to as much as 20 mg daily based upon efficacy and tolerance. Doses of 5 mg can be used if 10 mg doses are not tolerated. Common side effects include nausea, constipation, dizziness, somnolence, headache and dry mouth. Less common and rare side effects include mood disorders, suicidal ideation, sexual dysfunction, serotonin syndrome, discontinuation syndrome, increased risk of bleeding, hypersensitivity reactions and precipitation of manic episodes.

### Hepatotoxicity

Liver test abnormalities occur in a small proportion of patients (<1%) on long term therapy with vortioxetine, but elevations are usually mild, asymptomatic and transient, reversing even with continuation of medication. No instances of acute liver injury with jaundice have been reported attributable to vortioxetine, but the total experience with its use has been limited. However, most other SSRIs have been implicated in rare instances of clinically apparent liver injury. The latency to onset is typically 1 to 8 weeks and the pattern of enzyme elevations varies, ranging from cholestatic to hepatocellular. Mild signs and symptoms of hypersensitivity (rash, fever, eosinophilia) are common, but usually not prominent. Autoantibody formation is rare. The course is generally self-limited and mild-to-moderate in severity, but fatalities have been reported with some SSRIs. However, vortioxetine itself has not been implicated in similar cases.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which vortioxetine might cause serum aminotransferase elevations or liver injury is not known. Vortioxetine is metabolized by the liver via the cytochrome P450 system (predominantly CYP 2D6) and is susceptible to drug-drug interactions with agents that induce (rifampin, carbamazepine, phenytoin) or inhibit (bupropion, fluoxetine, quinidine) CYP 2D6 activity. Combination of vortioxetine with other serotonergic agents may precipitate the serotonin syndrome marked by fever, tachycardia, hypertension and agitation and can be accompanied by mild serum aminotransferase elevations.

### Outcome and Management

The serum aminotransferase elevations that occur on vortioxetine therapy are usually self-limited and do not require dose modification or discontinuation of therapy. No instances of acute liver failure or vanishing bile duct syndrome due to vortioxetine have been reported. There is no information on cross sensitivity to liver injury between vortioxetine and other antidepressants, but switching to another antidepressant after clinically apparent liver injury during vortioxetine therapy should be done with caution and adequate monitoring.

Drug Class: Antidepressant Agents

Other Drugs in the Subclass, SNRIs/SSRIs: Citalopram, Escitalopram, Duloxetine, Fluoxetine, Fluvoxamine, Levomilnacipran, Paroxetine, Sertraline, Venlafaxine, Vilazodone

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Vortioxetine – Trintellix®

DRUG CLASS

Antidepressant Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Vortioxetine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Vortioxetine | 508233-74-7 | C18-H22-N2-S

## ANNOTATED BIBLIOGRAPHY

References updated: 08 April 2020

Abbreviations: MAO inhibitor, monoamine oxidase inhibitor; SSRI, selective serotonin reuptake inhibitor; SNRI, serotonin and norepinephrine reuptake inhibitor.

Zimmerman HJ. Antidepressants. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 493-8. (Expert review of hepatotoxicity of antidepressants published in 1999; vortioxetine is not discussed).
Larrey D, Ripault MP. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 443-62. (Review of antidepressant hepatotoxicity; vortioxetine is not discussed).
O'Donnell JM, Bies RR, Shelton RC. Drug therapy of depression and anxiety disorders. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 267-77. (Textbook of pharmacology and therapeutics: vortioxetine is not mentioned).
Katona C, Hansen T, Olsen CK. (2012). A randomized, double-blind, placebo-controlled, duloxetine-referenced, fixed-dose study comparing the efficacy and safety of Lu AA21004 in elderly patients with major depressive disorder. Int Clin Psychopharmacol. (Among 452 patients with major depression treated with vortioxetine, duloxetine or placebo for 8 weeks, no patient developed a liver related serious adverse event and "no clinically relevant changes over time or differences between treatment groups were seen in clinical laboratory test results").
(2013). Vortioxetine (Brintellix) for depression. Med Lett Drugs Ther. (Concise review of mechanism of action, efficacy, adverse effects and costs of vortioxetine mentions that the most common adverse effects were nausea, vomiting and constipation; weight gain is uncommon and sexual dysfunction can occur in both women and men; no mention of ALT elevations or hepatotoxicity).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, Presentation and Outcomes in Patients with Drug-Induced Liver Injury in the General Population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to vortioxetine).
Park SH, Ishino R. (2013). Liver injury associated with antidepressants. Curr Drug Saf. (Review of drug induced liver injury due to antidepressants; vortioxetine is not mentioned).
Montgomery SA, Nielsen RZ, Poulsen LH. (2014). Häströ. A randomised, double-blind study in adults with major depressive disorder with an inadequate response to a single course of selective serotonin reuptake inhibitor or serotonin-noradrenaline reuptake inhibitor treatment switched to vortioxetine or agomelatine. Hum Psychopharmacol. (Among 495 patients with major depression not responding adequately to SSRI therapy who were treated with either vortioxetine or agomelatine for 12 weeks, one patient on agomelatine was withdrawn from therapy because of ALT elevations [>3 times ULN], but there were no other "clinically relevant changes over time or differences between treatment groups" in clinical laboratory results).
McIntyre RS, Lophaven S, Olsen CK. (2014). A randomized, double-blind, placebo-controlled study of vortioxetine on cognitive function in depressed adults. Int J Neuropsychopharmacol. (Among 591 patients with major depressive disorders treated with vortioxetine [10 or 20 mg daily] or placebo for 8 weeks, common side effects were nausea and headache, and laboratory test results showed no "clinically relevant changes over time or differences between treatment groups").
Mahableshwarkar AR, Jacobsen PL, Serenko M, Chen Y. (2014). A randomized, double-blind, fixed-dose study comparing the efficacy and tolerability of vortioxetine 2.5 and 10 mg in acute treatment of adults with generalized anxiety disorder. Hum Psychopharmacol. (Among 457 patients with generalized anxiety disorder treated with vortioxetine [2.5 or 20 mg] or placebo daily for 8 weeks, there were no improvements in measures of anxiety in the drug treated groups and no differences in clinical laboratory values nor "trends warranting safety concerns").
Mahableshwarkar AR, Jacobsen PL, Chen Y, Simon JS. (2014). A randomised, double-blind, placebo-controlled, duloxetine-referenced study of the efficacy and tolerability of vortioxetine in the acute treatment of adults with generalised anxiety disorder. Int J Clin Pract. (In a controlled trial of 8 weeks of vortioxetine [2.5, 5 or 10 mg daily], duloxetine or placebo is 781 patients with generalized anxiety disorder, no liver related serious adverse reactions were reported and "changes in serum chemistry... parameters were distributed evenly across vortioxetine and placebo groups" with "no discernible patterns of concern").
Boulenger JP, Loft H, Olsen CK. (2014). Efficacy and safety of vortioxetine (Lu AA21004), 15 and 20 mg/day: a randomized, double-blind, placebo-controlled, duloxetine-referenced study in the acute treatment of adult patients with major depressive disorder. Int Clin Psychopharmacol. (Among 608 patients with major depression treated for 8 weeks with vortioxetine [15 or 20 mg daily], duloxetine or placebo, there were no "clinically relevant changes over time or differences between treatment groups" in clinical laboratory test results).
Alam MY, Jacobsen PL, Chen Y, Serenko M, Mahableshwarkar AR. (2014). Safety, tolerability, and efficacy of vortioxetine (Lu AA21004) in major depressive disorder: results of an open-label, flexible-dose, 52-week extension study. Int Clin Psychopharmacol. (Among 834 patients with major depression participating in short term controlled trials of vortioxetine who were then treated with a further 52 weeks of flexible doses of the drug, the most frequent adverse events were mild-to-moderate nausea, headache, pharyngitis, diarrhea and dizziness; ALT elevations above 3 times ULN occurred in 0.4% and AST elevations in 0.7%, but these were asymptomatic and did not require drug discontinuation).
Voican CS, Corruble E, Naveau S, Perlemuter G. (2014). Antidepressant-induced liver injury: a review for clinicians. Am J Psychiatry. (Review of the frequency and clinical features of drug induced liver injury due to antidepressants; SSRIs such as venlafaxine, fluoxetine, sertraline and paroxetine are discussed, but not vortioxetine).
Hernández N, Bessone F, Sáhez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, one of which was attributed to an antidepressant [amitriptyline], but none were attributed to vortioxetine).
Zhang J, Mathis MV, Sellers JW, Kordzakhia G, Jackson AJ, Dow A, Yang P, et al. (2015). The US Food and Drug Administration's perspective on the new antidepressant vortioxetine. J Clin Psychiatry. (FDA summary of safety and efficacy analyses of data submitted on 7666 volunteers and patients treated with vortioxetine [5 to 20 mg daily] discusses 6 deaths [none liver related] and common non-serious adverse events [nausea, vomiting, constipation], without mentioning ALT elevations or hepatotoxicity).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 20 cases were attributed to antidepressants, including 5 to SSRIs [fluoxetine, escitalopram, sertraline], 9 to SNRIs [duloxetine, trazodone, nefazodone], but none to vortioxetine).
Jacobsen PL, Harper L, Chrones L, Chan S, Mahableshwarkar AR. (2015). Safety and tolerability of vortioxetine (15 and 20 mg) in patients with major depressive disorder: results of an open-label, flexible-dose, 52-week extension study. Int Clin Psychopharmacol. (In an open label study of 1075 patients treated with vortioxetine for 52 weeks, "The increased risk for hepatotoxicity that was reported with agomelatine treatment was not observed on long-term exposure to vortioxetine").
Mahableshwarkar AR, Zajecka J, Jacobson W, Chen Y, Keefe RS. (2015). A randomized, placebo-controlled, active-reference, double-blind, flexible-dose study of the efficacy of vortioxetine on cognitive function in major depressive disorder. Neuropsychopharmacology. (Among 602 patients with major depression treated with vortioxetine, duloxetine or placebo for 8 weeks, there were no "clinically significant findings within or differences between groups" in clinical chemistry results).
Baldwin DS, Chrones L, Florea I, Nielsen R, Nomikos GG, Palo W, Reines E. (2016). The safety and tolerability of vortioxetine: Analysis of data from randomized placebo-controlled trials and open-label extension studies. J Psychopharmacol. (Pooled analysis of 11 controlled trials and 5 extension studies of vortioxetine in 5701 patients with major depression found the most common adverse events was nausea [21% to 31%] and that it had “no effect relative to placebo on clinical laboratory parameters”).
Nishimura A, Aritomi Y, Sasai K, Kitagawa T, Mahableshwarkar AR. (2018). Randomized, double-blind, placebo-controlled 8-week trial of the efficacy, safety, and tolerability of 5, 10, and 20 mg/day vortioxetine in adults with major depressive disorder. Psychiatry Clin Neurosci. (Among 600 Japanese patients with major depression treated with vortioxetine [5, 10 or 20 mg] or placebo daily for 8 weeks, response rates were not significantly higher in the treated arms and side effects that were more common with vortioxetine included nausea, dizziness and insomnia; one patient discontinued therapy early because of abnormal liver tests, but details not provided).
Lochmann D, Richardson T. (2019). Selective serotonin reuptake inhibitors. Handb Exp Pharmacol. (Overview of the SSRIs mentioned that they have similar efficacy in treating depression and similar rates and adverse event profile which largely represents the effects of serotonin excess: nausea, diarrhea, dizziness, somnolence, insomnia, sweating, tremor anxiety, dry mouth, anxiety and restlessness; they can also cause weigh gain and sex dysfunction as well as activate mania and cause withdrawn symptoms).
Schwasinger-Schmidt TE, Macaluso M. (2019). Other antidepressants. Handb Exp Pharmacol. (Review of mechanism of action, pharmacology, clinical efficacy and side effects of atypical antidepressants including vortioxetine which is a mixed serotonin receptor agonist and antagonist which results in an increase in serotonergic transmission, whose major side effects are nausea and diarrhea and can cause increase risk of bleeding and hyponatremia; no discussion of hepatic side effects).
(2020). Drugs for depression. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of drugs for depression; hepatotoxicity is mentioned only for nefazodone [now rarely used because of severe hepatotoxicity] and duloxetine [in heavy drinkers]).

## OTHER REFERENCE LINKS

1 Recent References on Vortioxetine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Vortioxetine+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Vortioxetine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Vortioxetine)